# Metoclopramide

## OVERVIEW

### Introduction

Metoclopramide is an oral prokinetic and antiemetic agent used in the therapy of gastroesophageal reflux disease, gastroparesis and severe or chemotherapy induced nausea. Metoclopramide has been linked to rare instances of clinically apparent liver injury that are typically cholestatic and can be associated with bile duct loss.

### Background

Metoclopramide is a benzamide (a para-aminobenzoic acid derivative) which acts as a prokinetic agent on the gastrointestinal tract and an antiemetic, particularly in persons with gastrointestinal dysmotility. Its mechanism of action is uncertain; it is a serotonin type 4 (5-HT4) receptor agonist, but also has antagonist activity against vagal and central 5HT3 receptors and dopamine type 2 (D2) receptors. It increases the tone and amplitude of gastric contractions, relaxes the pyloric sphincter and increases peristalsis in the duodenum and jejunum, resulting in improved gastrointestinal motility and accelerated gastric emptying. Metoclopramide was approved for use in the United States in 2005 and is widely used in therapy of nausea, vomiting and gastrointestinal motility disorders including gastroparesis, with more than 6 million prescriptions being filled yearly. Metoclopramide is available as 5 and 10 mg tablets in generic forms and under the brand name Reglan. It is also available as a liquid solution for oral use and in injectable forms. The typical oral dose for gastroesophageal reflux and gastroparesis in adults is 10 to 15 mg taken 30 minutes before meals. Intravenous and intramuscular formulations are used for therapy of postoperative or chemotherapy induced nausea and vomiting. Therapy should not exceed 12 weeks in duration. Common side effects include restlessness, drowsiness, dizziness, headache, fatigue, diarrhea and polyuria. Chronic therapy has been associated with episodes of dystonia, oculogyric crises and extrapyramidal syndromes including tardive dyskinesia and Parkinson like symptoms for which it has a “black box” warning.

### Hepatotoxicity

Serum aminotransferase elevations during metoclopramide therapy are uncommon and rates of such elevations were not reported in the large clinical trials demonstrating its efficacy in motility disorders. Metoclopramide has been listed as a cause of clinically apparent liver injury in several large series of drug induced liver disease, but without documentation of the nature of the injury or degree of causality assessment. Clinical descriptions of liver injury attributable to metoclopramide are few, but the latency to onset of liver injury is usually less than 30 days and the pattern of liver enzyme elevations cholestatic. Immunoallergic features are not prominent. Prolonged jaundice and persistent pruritus suggestive of bile duct loss and vanishing bile duct syndrome has been described. Metoclopramide has not been listed as a cause of acute liver failure in large clinical series.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

Metoclopramide has little active hepatic metabolism and is excreted largely unchanged in the urine. The clinically apparent liver disease attributed to metoclopramide is probably immune mediated.

### Outcome and Management

Most instances of liver injury due to metoclopramide have been self-limiting and resolve upon withdrawal of the agent. A single instance of vanishing bile duct syndrome has been described. Little is known about cross sensitivity with other prokinetic medications.

Drug Class: Gastrointestinal Agents, Antiemetics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Metoclopramide – Generic, Reglan®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Metoclopramide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Metoclopramide | 364-62-5 | C14-H22-Cl-N3-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 03 February 2020

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 mentions that metoclopramide by itself has not been incriminated in any cases of hepatitis).
Sharkey KA, MacNaughton WK. Gastrointestinal motility and water flux, emesis and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics; metoclopramide is a prokinetic agent which improves gastric emptying and the symptoms of nausea and vomiting caused by gastrointestinal dysmotility syndromes).
Feurle GE. Arteriovenous shunting and cholestasis in hepatic hemangiomatosis associated with metoclopramide. Gastroenterology 1990; 99: 258-62. 2344931 (22 year old woman developed abdominal pain 4 months after starting metoclopramide and oral contraceptives, and was found to have multiple hepatic hemangiomatosis which worsened during therapy [bilirubin rising to 2.6 mg/dL, AST 26 U/L, Alk P 325 rising to 1700 U/L] and appeared to improve after metoclopramide was stopped, but patient still had marked Alk P elevations 2 years later).
Hainsworth J, Harvey W, Pendergrass K, Kasimis B, Oblon D, Monaghan G, Gandara D, et al. A single-blind comparison of intravenous ondansetron, a selective serotonin antagonist, with intravenous metoclopramide in the prevention of nausea and vomiting associated with high-dose cisplatin chemotherapy. J Clin Oncol 1991; 9: 721-8. 1826739 (Among 307 patients receiving cisplatin chemotherapy, ALT elevations above twice ULN occurred in 6% of those receiving ondansetron vs 0% on metoclopramide for prevention of nausea and vomiting, but all abnormalities were asymptomatic and resolved within 2 weeks).
Desta Z, Wu GM, Morocho AM, Flockhart DA. The gastroprokinetic and antiemetic drug metoclopramide is a substrate and inhibitor of cytochrome P450 2D6. Drug Metab Dispos 2002; 30: 336-43. 11854155 (Metoclopramide is metabolized by CYP 2D6 and may affect the clearance of drugs that are cleared by this isoenzyme).
Lata PF, Pigarelli DL. Chronic metoclopramide therapy for diabetic gastroparesis. Ann Pharmacother 2003; 37: 122-6. 12503946 (Review of efficacy and safety of metoclopramide in gastroparesis mentions that it has adverse effects in up to 20% of patients, mostly drowsiness and lethargy, but that tardive dyskinesia can occur with long term use; no mention of ALT abnormalities or hepatotoxicity).
Henzi I, Walder B, Tramèr MR. Metoclopramide in the prevention of postoperative nausea and vomiting: a quantitative systematic review of randomized, placebo-controlled studies. Br J Anaesth 1999; 83: 761-71. 10690140 (Systematic review of 66 studies, including 3260 patients receiving metoclopramide for postoperative nausea and vomiting and 3006 controls, reported no differences in rates of adverse events, but ALT elevations and hepatotoxicity were not mentioned).
Chevallier B, Cappelaere P, Splinter T, Fabbro M, Wendling JL, Cals L, Catimel G, et al. A double-blind, multicentre comparison of intravenous dolasetron mesilate and metoclopramide in the prevention of nausea and vomiting in cancer patients receiving high-dose cisplatin chemotherapy. Support Care Cancer 1997; 5: 22-30. 9010986 (Among 226 patients with cancer receiving cisplatin, 4% of 157 receiving dolasetron vs 1% receiving metoclopramide developed liver test abnormalities).
Bruera ED, MacEachern TJ, Spachynski KA, LeGatt DF, MacDonald RN, Babul N, Harsanyi Z, et al. Comparison of the efficacy, safety, and pharmacokinetics of controlled release and immediate release metoclopramide for the management of chronic nausea in patients with advanced cancer. Cancer 1994; 74: 3204-11. 7982184 (Among 34 patients with cancer treated with controlled or immediate release metoclopramide to prevent nausea and vomiting from chemotherapy, side effects were similar with the two formulations; no mention made of ALT elevations or hepatotoxicity).
Sledge GW Jr, Einhorn L, Nagy C, House K. Phase III double-blind comparison of intravenous ondansetron and metoclopramide as antiemetic therapy for patients receiving multiple-day cisplatin-based chemotherapy. Cancer 1992; 70: 2524-8. 1423181 (Among 45 patients with cancer receiving cisplatin based chemotherapy, 1 of 22 patients who were treated with metoclopramide versus 3 of 23 on ondansetron developed serum ALT elevations, but none developed signs of symptoms of liver injury).
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. 15206996 (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury; 5 cases were due to metoclopramide including 2 hepatocellular and 3 cholestatic, 4 with jaundice and 4 with latency of <30 days; odds ratio compared to population was 6.2; incidence of 12 per 100,000 users).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. 17539979 (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain calculated relative risk of injury compared to the general population: 7 cases were attributed to metoclopramide, giving a relative risk 4.1 and incidence 1.7 per 100,000 person years of exposure).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. 18955056 (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no cases were attributed to an antiemetic or metoclopramide).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. 20949552 (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to antiemetic agents or metoclopramide).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. 21039766 (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic, but neither metoclopramide or any antiemetic was listed among the 41 most commonly implicated agents).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. 23419359 (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to antiemetics or metoclopramide).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. 24552865 (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; antiemetics and metoclopramide were not listed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to metoclopramide: a 51 year old man developed jaundice one month after starting metoclopramide for gastroparesis [bilirubin 6.9 mg/dL, ALT 779 U/L, Alk P 859], with jaundice lasting 5 months followed by intermittent but persistent pruritus and Alk P elevations suggestive of bile duct paucity).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77. 27981596 (Among 26 patients with drug induced liver injury and liver biopsy findings of bile duct loss, one was attributed to metoclopramide: Chalasani [2015]).
Meegada S, Heda RP, Satapathy S, Verma R. Metoclopramide-induced serotonin syndrome. Cureus 2019; 11: e6359. 31938643 (28 year old woman with suicidal acetaminophen overdose [initial bilirubin 3.4, ALT 7982 U/L, Alk P 142 U/L, INR 5.3] and was recovering rapidly and being treated with intravenous metoclopramide when she developed tachycardia, hypertension, tremor, hyperreflexia and clonus suggestive of serotonin syndrome, which resolved within 36 hours of stopping metoclopramide and did not appear to worsen the liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Metoclopramide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Metoclopramide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Metoclopramide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Metoclopramide)